# Burosumab

## OVERVIEW

### Introduction

Burosumab is a human monoclonal antibody to fibroblast growth factor 23 (FGF23) which is used in the treatment of X-linked hypophosphatemia. Burosumab therapy has not been associated with serum enzyme elevations during therapy nor has it been implicated in cases of clinically apparent drug induced liver injury with jaundice.

### Background

Burosumab (bur oh' sue mab) is a recombinant, human IgG1 monoclonal antibody to fibroblast growth factor 23 (FGF23) which is used in the treatment of X-linked hypophosphatemia which is associated with excessive FGF23 production. X-linked hypophosphatemia is the most common cause of congenital rickets and is caused by mutations in genes that regulate FGF23 production which result in excessive circulating levels that cause phosphate wasting and poor bone mineralization. Patients have limb deformities, frequent fractures, short stature and musculoskeletal pain and stiffness. Binding of the monoclonal antibody to circulating FGF23 blocks its activity and results in increases in serum phosphate, decreases in alkaline phosphatase and improvements in clinical symptoms and rickets severity. Burosumab was approved for use in the United States in 2018, and current indications are for adults and children above 1 year of age with X-linked hypophosphatemia. Burosumab is available in single use vials of 10, 20 or 30 mg/mL under the brand name Crysvita. It is given subcutaneously and the dose and frequency of administration (every 2 or 4 weeks) varies by age and body weight. Side effects of are uncommon but can include injection site reactions, headache and back and leg pains. Rare, potentially severe side effects include severe hypersensitivity reactions and hyperphosphatemia.

### Hepatotoxicity

In prelicensure clinical trials, burosumab was not associated with changes in serum aminotransferase levels during therapy and rates of most adverse reactions were similar in patients who received burosumab as placebo. There have been no published reports of clinically apparent acute liver injury attributed to burosumab therapy.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Liver Injury

Burosumab is a human monoclonal antibody and is unlikely to be inherently hepatotoxic. While most recombinant proteins are metabolized by the liver, the metabolism leads largely to small peptides and amino acids which may be reused to synthesize proteins and are unlikely to be toxic or immunogenic. Inhibition of FGF23 does not appear to have an adverse effect on liver function.

Drug Class: Genetic Disorder Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Burosumab – Crysvita®

DRUG CLASS

Genetic Disorder Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Burosumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Burosumab | 1610833-03-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 08 August 2018

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists"; burosumab is not specifically mentioned).
Friedman PA. Agents affecting mineral ion homeostasis and bone turnover. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1275-306. (Textbook of pharmacology).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Insogna KL, Briot K, Imel EA, Kamenický P, Ruppe MD, Portale AA, Weber T, et al.; AXLES 1 Investigators. A randomized, double-blind, placebo-controlled, phase 3 trial evaluating the efficacy of burosumab, an anti-FGF23 antibody, in adults with X-linked hypophosphatemia: week 24 primary analysis. J Bone Miner Res 2018; 33: 1383-93. (Among 134 adults with X-linked hypophosphatemia treated with burosumab or placebo every 4 weeks for 24 weeks, serum phosphate levels rose into the normal range [in 94% vs 8%] and stiffness and pain scores improved with burosumab, while adverse event rates were similar in the 2 groups; no mention of ALT elevations or hepatotoxicity). 29947083
Kinoshita Y, Fukumoto S. X-Linked hypophosphatemia and FGF23-related hypophosphatemic diseases: prospect for new treatment. Endocr Rev 2018; 39: 274-91. (Review of the molecular basis, pathogenesis, clinical features and therapy of FGF23 related hypophosphatemic syndromes). 29381780
Lamb YN. Burosumab: first global approval. Drugs 2018; 78: 707-14. (Review of the mechanism of action, development, pharmacology, clinical efficacy and safety of burosumab shortly after its approval for use in X-linked hypophosphatemia). 29679282

## OTHER REFERENCE LINKS

1. Recent References on Burosumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Burosumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Burosumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Burosumab)